# Neratinib

## OVERVIEW

### Introduction

Neratinib is an orally available tyrosine kinase receptor inhibitor that is used in the extended adjuvant therapy of early stage breast cancer. Neratinib is associated with a low rate of transient elevations in serum aminotransferase levels during therapy, but has not been convincingly linked to cases of clinically apparent liver injury with jaundice.

### Background

Neratinib (ne ra' ti nib) is a small molecule tyrosine kinase receptor inhibitor with potent activity against human epidermal growth factor receptor 2 (HER2 or ErbB2). These tyrosine kinase receptors are often mutated and over expressed in tumor tissue and cause unregulated cell growth and proliferation. This mutation is present in 20% of breast cancers and is particularly overexpressed in early stage cancers. Inhibition of the unregulated receptor can lead to reversal of progression of the cancer, although clinical responses are sometimes limited by the development of tumor resistance caused by further mutations in the receptor gene. In several large controlled trials, adjuvant therapy with neratinib was shown to improve progression free survival in patients with early stage, HER2-positive breast cancer. Neratinib received approval for use in the United States in 2017. Current indications are as extended adjuvant therapy for early stage, HER2-positive breast cancer following trastuzumab treatment. Neratinib is available in tablets of 40 mg under the brand name Nerlynx. The recommended dose is 240 mg (6 tablets) once daily for one year or until intolerable toxicity occurs. Side effects are common and particularly diarrhea [95%], which can be severe and dose limiting and for which prophylaxis with antidiarrheal agents is recommended. Other frequent side effects include nausea, abdominal pain, anorexia, weight loss, abdominal distension, fatigue, rash, stomatitis, dry skin, paronychia, muscle spasms and urinary treat infections. Uncommon, but potentially severe side effects include severe diarrhea leading to dehydration and renal failure, and embryo-fetal toxicity.

### Hepatotoxicity

Elevations in serum aminotransferase levels are not uncommon during neratinib therapy occurring in up to 10% of patients, but rising above 5 times the upper limit of the normal range in only 1% to 2%. In prelicensure studies, there were no instances of neratinib related clinically apparent liver injury and serum enzyme elevations were typically mild and self-limited and not associated with symptoms or jaundice. Hepatotoxicity may be a class effect among protein kinase inhibitors of HER2, although the frequency and severity vary among the different agents. Specific details of the liver injury associated with neratinib such as latency, serum enzyme pattern, clinical features and course, have not been published. Other tyrosine kinase receptor inhibitors typically cause liver injury arising within days or weeks of starting therapy and presenting abruptly with hepatocellular enzyme elevations and a moderate-to-severe course. Immunoallergic and autoimmune features are not common. The rate of clinically significant liver injury and hepatic failure is increased in patients with preexisting cirrhosis or hepatic impairment due to liver tumor burden. Nevertheless, neratinib has not been convincingly linked to instances of clinically apparent liver injury.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The abrupt and severe nature of the clinically apparent liver injury attributed to EGF receptor inhibitors suggests that it is immunologically mediated. On the other hand, the transient serum enzyme elevations that are not uncommon during therapy suggest a direct, intrinsic hepatotoxicity, perhaps caused by inhibition of critical tyrosine kinase receptors in hepatocytes. Neratinib is metabolized in the liver largely by the cytochrome P450 system and is susceptible to drug-drug interactions with inhibitors or inducers of CYP 3A4.

### Outcome and Management

Liver injury due to neratinib has largely been in the form of asymptomatic, transient serum enzyme elevations. Monitoring of liver tests during neratinib therapy is recommended before treatment, monthly for the first 3 months and every 3 months thereafter or as clinically indicated. Serum aminotransferase elevations above 5 times the upper limit of normal should lead to temporary discontinuation, which should be permanent if laboratory values worsen or do not resolve or improve significantly within a few weeks, or if symptoms or jaundice arises. Restarting therapy is usually, but not always followed by recurrence of the serum enzyme elevations. There does not appear to be cross reactivity with other tyrosine kinase receptor inhibitors and, in some situations, switching to another protein kinase inhibitor may be appropriate.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Neratinib – Nerlynx®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Neratinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Neratinib | 698387-09-6 | C26-H23-N7-O2 | Neratinib structure

## ANNOTATED BIBLIOGRAPHY

References updated: 20 October 2018

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents; mentions that tyrosine kinase inhibitors have been linked to cases of clinically apparent liver injury, some of which were fatal).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-54. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy).
Martin M, Bonneterre J, Geyer CE Jr, Ito Y, Ro J, Lang I, Kim SB, et al. A phase two randomised trial of neratinib monotherapy versus lapatinib plus capecitabine combination therapy in patients with HER2+ advanced breast cancer. Eur J Cancer 2013; 49: 3763-72. (Among 233 women with HER2 positive breast cancer and previous trastuzumab treatment, median overall survival was 20 months in those receiving neratinib vs 24 months in those on lapatinib with capecitabine, while side effects, dose reductions and discontinuations were less with neratinib including ALT elevations [7% vs 13%]; there were no liver related serious adverse events or deaths in either group). 23953056
Saura C, Garcia-Saenz JA, Xu B, Harb W, Moroose R, Pluard T, Cortés J, et al. Safety and efficacy of neratinib in combination with capecitabine in patients with metastatic human epidermal growth factor receptor 2-positive breast cancer. J Clin Oncol 2014; 32: 3626-33. (Among 104 women with HER2 positive breast cancer treated with varying doses of neratinib and capecitabine for up to 99 weeks, ALT elevations arose in 3 [3%], but there were no cases of ALT elevations with jaundice). 25287822
Takeda M, Okamoto I, Nakagawa K. Pooled safety analysis of EGFR-TKI treatment for EGFR mutation-positive non-small cell lung cancer. Lung Cancer 2015; 88: 74-9. (In a pooled analysis of 21 trials of tyrosine kinase inhibitors of EGFR found higher reported rates of "grade 3" hepatotoxicity with gefitinib [18%] than with erlotinib [5.4%] and afatinib [1.7%], and hepatotoxicity was listed as the cause of drug discontinuation in 25% of cases). 25704957
Awada A, Colomer R, Inoue K, Bondarenko I, Badwe RA, Demetriou G, Lee SC, et al. Neratinib plus paclitaxel vs trastuzumab plus paclitaxel in previously untreated metastatic ERBB2-positive breast cancer: The NEfERT-T Randomized Clinical Trial. JAMA Oncol 2016; 2: 1557-64. (Among 479 women with metastatic HER2 positive breast cancer treated with paclitaxel and either neratinib or trastuzumab, progression free survival was similar in the two groups while adverse events were more frequent with neratinib including diarrhea [93% vs 33%], nausea [44% vs 30%], weight loss [16% vs 5%] and ALT elevations [any elevation: 13% vs 11%; above 5 times ULN: 5% vs 2%]). 27078022
Chan A, Delaloge S, Holmes FA, Moy B, Iwata H, Harvey VJ, Robert NJ, et al.; ExteNET Study Group. Neratinib after trastuzumab-based adjuvant therapy in patients with HER2-positive breast cancer (ExteNET): a multicentre, randomised, double-blind, placebo-controlled, phase 3 trial. Lancet Oncol 2016; 17: 367-77. (Among 2840 women with HER2 positive breast cancer after trastuzumab adjuvant therapy, invasive disease free survival was greater with a one year course of neratinib than with placebo therapy [94% vs 92%], but was also associated with a higher rate of adverse events including diarrhea [40% vs 1.6%] and ALT elevations above 5 times ULN [1.1% vs 0.3%], but there were no cases of clinically apparent liver injury). 26874901
Park JW, Liu MC, Yee D, Yau C, van 't Veer LJ, Symmans WF, Paoloni M, et al.; I-SPY 2 Investigators. Adaptive randomization of neratinib in early breast cancer. N Engl J Med 2016; 375: 11-22. (Among 193 women with early breast cancer treated with standard neoadjuvant chemotherapy with or without neratinib, adverse events were more frequent with neratinib including diarrhea [96% vs 50%] and ALT elevations [37% vs 12%], which were above 5 times ULN in 11% vs 1%, although there were no liver related severe adverse events in either group). 27406346
Martin M, Holmes FA, Ejlertsen B, Delaloge S, Moy B, Iwata H, von Minckwitz G, et al.; ExteNET Study Group. Neratinib after trastuzumab-based adjuvant therapy in HER2-positive breast cancer (ExteNET): 5-year analysis of a randomised, double-blind, placebo-controlled, phase 3 trial. Lancet Oncol 2017; 18: 1688-1700. (A 5 year follow up on 2840 women with HER2 positive breast cancer treated with a one year course of neratinib vs placebo [Chan 2016] found continued improved invasive disease free survival [90% vs 88%] and no new safety signals). 29146401
Ding PN, Lord SJ, Gebski V, Links M, Bray V, Gralla RJ, Yang JC, et al. Risk of treatment-related toxicities from EGFR tyrosine kinase inhibitors: a meta-analysis of clinical trials of gefitinib, erlotinib, and afatinib in advanced EGFR-mutated non-small cell lung cancer. J Thorac Oncol 2017; 12: 633-43. (In a systematic review of 16 trials of EGFR tyrosine kinase inhibitors, liver enzyme elevations were highest for gefitinib [62%] vs afatinib [20%] and erlotinib [18%]; does not mention neratinib). 28007626
Singh H, Walker AJ, Amiri-Kordestani L, Cheng J, Tang S, Balcazar P, Barnett-Ringgold K, et al. U.S. Food and Drug Administration approval: neratinib for the extended adjuvant treatment of early stage HER2-positive breast cancer. Clin Cancer Res 2018; 24: 3486-91. (Summary of evidence for the safety and efficacy of neratinib that led to its approval for the extended adjuvant treatment of women with early stage, HER2 positive breast cancer; mentions but does not discuss ALT and AST elevations during therapy). 29523624
Neratinib (Nerlynx) for HER2-positive breast cancer. Med Lett Drugs Ther 2018; 60 (1539): 23. (Concise review of the mechanism of action, clinical efficacy, safety and costs of neratinib shortly after its approval in the US for therapy of breast cancer; mentions that diarrhea is the most common side effect and that ALT and AST elevations occurred in 5-9% of treated patients versus 3-4% of controls). 29364199

## OTHER REFERENCE LINKS

1. Recent References on Neratinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Neratinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Neratinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Neratinib)